# Glucosamine

## OVERVIEW

### Introduction

Glucosamine is a popular nutritional supplement and natural component of cartilage that is frequently combined with chondroitin sulfate and used for osteoarthritis and nonspecific joint pain. Glucosamine has been implicated in isolated case reports in causing clinically apparent liver injury, but the role of glucosamine as opposed to other herbal components or contaminants has not been shown, and liver injury due to glucosamine or chondroitin must be very rare if it occurs at all.

### Background

Glucosamine (gloo kose' a meen) is a natural component of cartilage that is a widely used as an over-the-counter nutritional supplement purported to decrease the pain and cartilage loss of osteoarthritis. Glucosamine is commonly taken in combination with chondroitin (kon droe' i tin), which is a glycosaminoglycan that is also present in cartilage. Glucosamine is an amino sugar and a prominent molecule in the biochemical pathways of synthesis of glycosylated proteins and lipids. It is also a major component of keratin sulfate and hyaluronic acid which are present in articular cartilage and synovial fluid. Both glucosamine and chondroitin are reduced in osteoarthritis. Glucosamine is commercially available alone and in combination with chondroitin and widely used for osteoarthritis and arthritic pain. Controlled trials of glucosamine with and without chondroitin have yielded conflicting results. In the largest US study of glucosamine for early osteoarthritis, glucosamine alone and the combination of glucosamine and chondroitin were no more beneficial than placebo in alleviating joint pain or preventing progression of cartilage damage. Glucosamine is typically taken in doses of 500 mg three times daily and chondroitin sulfate in doses of 200 to 400 mg three times daily. Side effects are uncommon and mild and may include abdominal discomfort, nausea, fatigue and headache; but in placebo controlled trials, side effects during glucosamine therapy were no more frequent than with receipt of placebo.

### Hepatotoxicity

In controlled trials, glucosamine and its combination with chondroitin have not been linked to serum enzyme elevations or to instances of clinically apparent liver injury. In addition, cases of clinically apparent liver injury have not been reported from prospective trials. Recently, several cases reports and small series of clinically apprent liver injury attributed to glucosamine (with or without chondroitin) have been published, but the relationship of glucosamine itself as opposed to other herbals in the implicated products or to potential contaminants, remains unclear and several cases were considered only "possibly" related to glucosamine. The time to onset is usually 1 to 4 weeks after starting the preparation and the pattern of injury is typically hepatocellular or mixed. At least one instance of acute liver failure has been reported. Immunoallergic features (rash, fever, eosinophilia) can occur, but are usually not prominent. Most patients were reported to recover within 4 to 8 weeks of stopping. There have not been instances of rechallenge with glucosamine, and the purity and concentration of glucosamine in the products used have not been reported.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which glucosamine or chondroitin might cause liver injury is unclear. Glucosamine is a simple amino sugar and chondroitin a glycosaminoglycan. Both are natural products found in cartillage in humans and mammals. The glucosamine in commercially available dietary supplements is usually prepared from the exoskeletons of shellfish or from fermentation of grain. The concentration, purity and freedom from contaminants in commercially available preparations of glucosamine and chondroitin is not always clear.

### Outcome and Management

The severity of the liver injury in reports of glucosamine hepatotoxicity has varied from mild, asymptomatic elevations in serum enzymes to clinically apparent hepatitis that can be severe and even fatal. There is no information on management or the role for corticosteroids or other interventions except for prompt discontinuation of the suspected agent.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute liver injury attributed to a glucosamine containing dietary and herbal supplement.

[Modified from: Ossendza RA, Grandval P, Chinoune F, Rocher F, Chapel F, Bernardini D. [Acute cholestatic hepatitis due to glucosamine forte]. Gastroenterol Clin Biol 2007; 31: 449-50. French.]

A 52 year old man developed weakness followed by jaundice and generalized itching arising 3 weeks after starting capsules of Glucosamine forte. He had no previous history of liver disease or drug allergies and denied alcohol abuse and risk factors for viral hepatitis. He had no other major medical illnesses and was taking glucosamine for low back pain. On presentation, physical examination revealed jaundice, but no fever or rash. Laboratory testing showed a total bilirubin of 10.9 mg/dL, ALT 263 U/L, AST 63 U/L, GGT 240 U/L and alkaline phosphatase 714 U/L (Table). He tested negative for markers of hepatitis A, B, C and E as well as EBV, cytomegalovirus and herpes simplex. Tests for autoantibodies were negative. Abdominal ultrasound and CT scans were normal with no evidence of biliary obstruction. A liver biopsy showed canalicular cholestasis, hepatocellular necrosis and lobular inflammation with one microgranuloma, which overall was considered compatible with drug induced liver injury. Glucosamine had been stopped a week before clinical presentation and his symptoms improved rapidly. Serum bilirubin rose to 13.9 and then gradually began to fall. Liver tests fell into the near normal range within 8 weeks of stopping the supplement and were completely normal when he was seen 4 months later.

#### Key Points

Medication: | Glucosamine
Pattern: | Mixed (R=2.5)
Severity: | 3+ (jaundice and hospitalized)
Latency: | 3 weeks to symptoms, 4 weeks to jaundice
Recovery: | 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
4 weeks | 7 days | 263 | 714 | 10.9 | Eosinophils 1140/uL
| 9 days | 190 | 690 | 13.9 | Liver biopsy
6 weeks | 3 weeks | 50 | 575 | 12.5
7 weeks | 4 weeks | 45 | 320 | 7.6
9 weeks | 6 weeks | 40 | 400 | 6.4
11 weeks | 8 weeks | 40 | 300 | 2.8
5 months | 5 months | 40 | 240 | 1.0
Normal Values | | <41 | <270 | <1.2

* Some values estimated from Figure 1.

#### Comment

This was a typical case of cholestatic-mixed hepatitis due to a medication, but in this instance the only drug being taken was a commercial preparation of glucosamine. Typical of cholestatic hepatitis was the presentation with pruritus and the somewhat delayed recovery. While the dietary supplement appears to be fairly convincingly implicated as the cause of the liver injury, what is uncertain is whether glucosamine per se versus a possible contaminant was responsible. Glucosamine is a simple amino sugar and is used by millions of people. Reports of hepatic injury from glucosamine are few (less than a dozen in the published literature) and always limited by the lack of proof of purity of the dietary supplement used.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glucosamine – Generic

Chondroitin sulfate – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

(Glucosamine Hydrochloride) Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/747.html)

(Glucosamine Sulfate) Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/807.html)

(Chondroitin Sulfate) Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/744.html)

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/glucosaminechondroitin)

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Glucosamine | 3416-24-8 | C6-H13-N-O5
Chondroitin Sulfate | 9007-28-7 | H2-O4-S.x-Unspecified

## ANNOTATED BIBLIOGRAPHY

References updated: 12 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; glucosamine and chondroitin are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbs and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; glucosamine and chondroitin are not discussed).
Glucosamine. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 967-71. (Compilation of short monographs on herbal medications and dietary supplements).
Reginster JY, Deroisy R, Rovati LC, Lee RL, Lejeune E, Bruyere O, Giacovelli G, et al. (2001). Long-term effects of glucosamine sulphate on osteoarthritis progression: a randomised, placebo-controlled clinical trial. Lancet. (Controlled trial from Belgium of 3 years of glucosamine sulphate vs placebo in 212 patients with osteoarthritis of the knees; found no differences in side effects and no serious adverse events attributable to glucosamine; no mention of hepatotoxicity or results of liver tests).
Pavelká K, Gatterová J, Olejarová M, Machacek S, Giacovelli G, Rovati LC. (2002). Glucosamine sulfate use and delay of progression of knee osteoarthritis: a 3-year, randomized, placebo-controlled, double-blind study. Arch Intern Med. (Controlled trial of from Italy of glucosamine sulphate vs placebo in 202 patients with knee osteoarthritis; there were no significant differences in frequency of adverse events between the two groups or in safety laboratory results; hepatotoxicity and ALT levels were not mentioned).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; glucosamine is not listed as causing hepatotoxicity).
Ossendza RA, Grandval P, Chinoune F, Rocher F, Chapel F, Bernardini D. (2007). Gastroenterol Clin Biol. (52 year old man developed jaundice and pruritus 1 week after stopping 3 week course of glucosamine for low back pain [bilirubin 10.9 mg/dL, ALT 263 U/L, Alk P 714 U/L, eosinophils 1140/uL], with biopsy showing cholestatic hepatitis and a granuloma, episode resolving within 2 months of stopping).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were attributed to glucosamine or chondroitin).
Rozendaal RM, Koes BW, van Osch GJ, Uitterlinden EJ, Garling EH, Willemsen SP, Ginai AZ, et al. (2008). Effect of glucosamine sulfate on hip osteoarthritis: a randomized trial. Ann Intern Med. (Controlled trial from the Netherlands of 2 years of glucosamine sulfate vs placebo in 222 patients with hip osteoarthritis; there was no significant differences in adverse events between the two groups and no serious adverse events related to the liver).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals but none were attributed to glucosamine or chondroitin).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications or dietary supplements, but none of the cases were linked to glucosamine or chondroitin).
Smith A, Dillon J. Acute liver injury associated with the use of herbal preparations containing glucosamine: three case studies. BMJ Case Rep 2009; 2009. (Three patients developed liver injury after taking glucosamine: 2 women and 1 man, ages 55-64 years, developed liver injury 5 days, 4 weeks and 6 months after starting the product [bilirubin 24.5, 11.6 mg/dL and normal; ALT 1461, 1130 and 175 U/L, Alk P 141, 198 and 187 U/L], one patient died of acute liver failure, a second developed cirrhosis and a third resolved without symptoms or jaundice; details of products not provided, but some included other potentially hepatotoxic herbals).
Wilkens P, Scheel IB, Grundnes O, Hellum C, Storheim K. (2010). Effect of glucosamine on pain-related disability in patients with chronic low back pain and degenerative lumbar osteoarthritis: a randomized controlled trial. JAMA. (Controlled trial from Norway of 6 months of glucosamine vs placebo in 250 patients with back pain and degenerative osteoarthritis; rates of adverse events were similar in the two groups: hepatotoxicity and ALT elevations were not mentioned).
Sawitzke AD, Shi H, Finco MF, Dunlop DD, Harris CL, Singer NG, Bradley JD, et al. (2010). Clinical efficacy and safety of glucosamine, chondroitin sulphate, their combination, celecoxib or placebo taken to treat osteoarthritis of the knee: 2-year results from GAIT. Ann Rheum Dis. (Controlled trial from US of 24 months of glucosamine, chondroitin, their combination, or celecoxib vs placebo in 662 patients with knee osteoarthritis; rates of adverse events were similar across treatment groups and no liver related serious adverse event occurred).
Miller KL, Clegg DO. (2011). Glucosamine and chondroitin sulfate. Rheum Dis Clin North Am. (Review of the structure, pharmacokinetics, possible mechanisms of action, clinical efficacy and safety of glucosamine and chondroitin as therapy for osteoarthritis; other than a possible interaction with warfarin, no serious adverse events have been linked to long term use of glucosamine and chondroitin).
Linnebur SA, Rapacchietta OC, Vejar M. Hepatotoxicity associated with chinese skullcap contained in Move Free Advanced dietary supplement: two case reports and review of the literature. Pharmacotherapy 2010; 30(7): 750, 258e-262e. (Abstract only: 2 patients developed liver injury after taking "Move Free Advanced", a dietary supplement which contains glucosamine, chondroitin and also extracts of several herbs including Chinese skullcap, which the authors suggested was the responsible agent).
Ebrahim V, Albeldawi M, Chiang DJ. Acute liver injury associated with glucosamine dietary supplement. BMJ Case Rep 2012; 2012. (55 year old woman developed jaundice 2 weeks after starting glucosamine [bilirubin 9.1 mg/dL, ALT 1553 U/L, Alk P 303 U/L], resolving within 4 weeks of stopping).
Cerda C, Bruguera M, Parés A. (2013). Hepatotoxicity associated with glucosamine and chondroitin sulfate in patients with chronic liver disease. World J Gastroenterol. (Transient elevations in serum ALT levels [from 33 and 53 to 282 and 162 U/L] were found in 2 patients with chronic hepatitis C taking glucosamine, which improved upon stopping [falling to 85 and 37 U/L]).
von Felden J, Montani M, Kessebohm K, Stickel F. (2013). Drug-induced acute liver injury mimicking autoimmune hepatitis after intake of dietary supplements containing glucosamine and chondroitin sulfate. Int J Clin Pharmacol Ther. (65 year old man developed severe autoimmune hepatitis while taking glucosamine and chondroitin sulfate [bilirubin 7.7 mg/dL, ALT 2744 U/L, Alk P 199 U/L, ANA negative, IgG 1820 mg/dL], which responded to corticosteroid therapy and was judged as "possibly" due to the supplement).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention glucosamine or chondroitin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to glucosamine or chondroitin).
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. (2014). Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea extract, but none to glucosamine or chondroitin).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, two of which were attributed to a glucosamine and chondroitin containing multiingredient nutirtional supplement).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; discussed glucosamine based supplements which are occasionally implicated in causing liver injury, but most were multiingredient products and included herbs).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], two of which were attributed to "Move Free" which contains glucosamine and chondroitin, but also other HDS components [Navarro 2014]).
Zeng C, Wei J, Li H, Wang YL, Xie DX, Yang T, Gao SG, et al. (2015). Effectiveness and safety of Glucosamine, chondroitin, the two in combination, or celecoxib in the treatment of osteoarthritis of the knee. Sci Rep. (Among).
Roman-Blas JA, Castañeda S, Sánchez-Pernaute O, Largo R, Herrero-Beaumont G, CS/GS Combined Therapy Study Group. (2017). Combined treatment With chondroitin sulfate and glucosamine sulfate shows no superiority over placebo for reduction of joint pain and functional impairment in patients With Knee Osteoarthritis: A Six-Month multicenter, randomized, double-blind, placebo-controlled clinical trial. Arthritis Rheumatol. (Among).
Hochberg MC, Martel-Pelletier J, Monfort J, Möller I, Castillo JR, Arden N, Berenbaum F, et al., MOVES Investigation Group. (2016). Combined chondroitin sulfate and glucosamine for painful knee osteoarthritis: a multicentre, randomised, double-blind, non-inferiority trial versus celecoxib. Ann Rheum Dis. (Among).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products does not discuss glucosamine and chondroitin).
Avigan MI, Mozersky RP, Seeff LB. (2016). Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions that glucosamine and chondroitin have been implicated in causing liver injury in four publications [Ossendza 2007, Smith 2009, Ebrahim 2012, Cerda 2013]).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products; does not mention glucosamine or chondroitin).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, pyrrolizidine alkaloids and proprietary multiingredint nutrition supplements [MINS] including "Move Free Advanced" which contains glucosamine and chrondroitin, but also skullcap).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug-induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically mentioning glucosamine or chondroitin).

## OTHER REFERENCE LINKS

1 Recent References on Glucosamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Glucosamine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Glucosamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Glucosamine)